# Hydroxyurea

## OVERVIEW

### Introduction

Hydroxyurea is an antimetabolite that is used in the treatment of cancer and to stimulate fetal hemoglobin production in sickle cell disease. Hydroxyurea is associated with a low rate of transient serum enzyme and bilirubin elevations during therapy, and has been implicated in rare cases of clinically apparent acute liver injury with jaundice.

### Background

Hydroxyurea (hye drox” ee ure ee’ a) is a hydroxylated analogue of urea and an antimetabolite which inhibits the enzyme ribonucleotide reductase, which is necessary for DNA synthesis and cell cycle replication. Blocking the enzyme results in cell cycle arrest in the S phase, but does not interfere with RNA or protein synthesis. Hydroxyurea is used in the treatment of solid tumors and myeloproliferative diseases, the latter because of its effects in reducing excessive production of red blood cells (polycythemia vera), white blood cells (chronic myelogenous leukemia) or platelets (essential thrombocythemia). Hydroxyurea also increases the production of fetal hemoglobin, via an unknown mechanism of action, which increases overall hemoglobin levels and decreases sickling in patients with sickle cell anemia. In controlled clinical trials, hydroxyurea has been shown to increase hemoglobin concentrations, decrease transfusion requirements and lessen painful crises in patients with sickle cell disease. Hydroxyurea was first approved for use in the United States in 1967 as an antineoplastic agent for therapy of melanoma, chronic myelogenous leukemia, ovarian carcinoma, and head and neck cancers. The indications were expanded to sickle cell disease in 1998, which is the major indication for its use at present. Hydroxyurea is available in capsules of 200, 300, 400 and 500 mg generically and under brand names as Droxia (for sickle cell disease) and Hydrea (for cancer). The usual dose in sickle cell disease is 15 mg/kg/day, with subsequent dose adjustments based upon efficacy and tolerance to a maximum of 35 mg/kg/day. Common side effects include bone marrow suppression (particularly thrombocytopenia), nausea, vomiting, anorexia, diarrhea, mucositis, hair loss, headache, rash and fever. Uncommon, but potentially severe adverse reactions include severe vasculitic skin ulcers, neuropathy, renal dysfunction, severe bone marrow suppression, pulmonary fibrosis, and embryo-fetal toxicity. Long term hydroxyurea therapy may increase the risk of cancer.

### Hepatotoxicity

Serum aminotransferase and bilirubin elevations occur in a small proportion of patients on conventional doses of hydroxyurea and a greater proportion at higher doses. However, the serum enzyme elevations are rarely associated with symptoms and are generally self-limited and resolve rapidly, rarely requiring dose modification.

Cases of clinically apparent liver injury attributed to hydroxyurea have been reported, but are rare. Two clinical presentations have been described: an acute syndrome of drug fever and mild hepatitis that resolves rapidly with stopping, and a less well characterized acute hepatitis-like injury which can be severe and even fatal, arising after several months of treatment and usually in patients on other hepatotoxic medications.

Drug fever occurs in up to 1% of patients treated with hydroxyurea, typically arising within 1 to 3 weeks of starting and presenting with high fevers and mild constitutional symptoms of fatigue and nausea (Case 1 below). The fevers are typically cyclic and temperature can rise to 41^o^C at intervals of every 1 to 3 days as long as therapy is continued. The fevers are generally well tolerated, although they may be accompanied by nausea, diarrhea, anorexia or fatigue. Approximately one third of patients will also have some degree of serum enzyme elevations, typically increases in both aminotransferase and alkaline phosphatase levels, with minimal increases in serum bilirubin. The liver injury is usually mild and asymptomatic and the symptom of fever predominates. White blood cell and eosinophil counts are usually normal at the time of onset, but may arise if therapy is continued. Rash and other signs of hypersensitivity are uncommon. Both the fever and liver test abnormalities resolve promptly once hydroxyurea is stopped–the fever within 24 to 48 hours and the liver test elevations within 2 to 4 weeks. The fever recurs with reexposure, generally within 24 hours.

In addition, rare instances of acute hepatitis that can be severe and lead to hepatic failure and death have been described in patients taking hydroxyurea and antiretroviral therapy for HIV/AIDS. This presentation is clearly different from the hepatitis that accompanies drug fever from hydroxyurea, and resembles acute viral hepatitis with marked elevations in serum aminotransferase levels and jaundice and only mild-to-moderate elevations in alkaline phosphatase. Immunoallergic and autoimmune features are not usually present. Some cases have been fatal; others have been marked by slow, but ultimately full recovery. The cases of severe hepatitis attributed to hydroxyurea have been described largely in patients with HIV infection on antiretroviral regimens that include agents associated with hepatotoxicity, but the addition of hydroxyurea appeared to be responsible for the liver injury, these patients later tolerating resumption of antiretroviral therapy without recurrence.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The syndrome of fever and acute hepatitis arising within 1 to 3 weeks of starting hydroxyurea is probably due to hypersensitivity. The cause of acute liver failure attributed to hydroxyurea is unknown, but may be related to drug-drug interactions with other potentially hepatotoxic agents. Hydroxyurea is metabolized in the liver via the cytochrome P450 enzymes at least in part, but its drug-drug interactions have not been well characterized.

### Outcome and Management

The severity of the liver injury linked to hydroxyurea therapy is usually mild and self-limited. It has not been linked to cases of chronic hepatitis or vanishing bile duct syndrome. There is no information to suggest that there is cross sensitivity to hepatic injury between hydroxyurea and other antimetabolites or anticancer agents.

Drug Class: Antineoplastic Agents, Miscellaneous; Genetic Disorder Agents, Hematologic Agents, Sickle Cell Disease Agents

## CASE REPORT

### Case 1. Fever and hepatitis due to hydroxyurea.(1)

A 46 year old woman with polycythemia vera developed spiking fevers 3 weeks after starting hydroxyurea [500 mg twice daily]. She had no history of liver disease, alcohol abuse or drug allergies or risk factors for viral hepatitis. Her only other medication was hydroxyzine. She was admitted to the hospital and continued to have spiking fevers to as high as 41.5 ^o^C for 8 days until hydroxyurea was stopped, whereupon the fever resolved within 24 hours. Liver test results were also abnormal, with peak values of bilirubin of 1.0 mg/dL, ALT 271 U/L, AST 135 U/L, alkaline phosphatase 1047 U/L and GGT 585 U/L. Tests for viral hepatitis were negative. In follow up, the liver test abnormalities evidently resolved. One year later, she was rechallenged with hydroxyurea and developed fever 24 hours later.

#### Key Points

Medication: | Hydroxyurea, 500 mg twice daily
Pattern: | Cholestatic (R=1.0)
Severity: | 1+ (enzyme elevations and symptoms without jaundice)
Latency: | 3 weeks
Recovery: | Not given
Other medications: | Hydroxyzine

#### Comment

Drug fever occurs in approximately 1% of patients treated with hydroxyurea, but is generally benign and rapidly reversible with drug discontinuation. Liver tests abnormalities are reported in about one third of cases, but typically in patients in whom the drug is continued for several days or weeks in the face of recurrent fevers, as occurred in this case. The liver test abnormalities are usually mild, anicteric and resolve within 2 to 4 weeks of stopping the medication. The pattern of serum enzyme elevations is typically mixed or cholestatic, but hepatocellular instances have also been reported. In rare instances, jaundice has occurred, but there have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome attributed to hydroxyurea associated hepatitis with drug fever.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hydroxyurea – Generic, Hydrea® (for cancer), Droxia® (for sickle cell disease)

DRUG CLASS

Antineoplastic Agents; Sickle Cell Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hydroxyurea)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Hydroxyurea | 127-07-1 | C-H4-N2-O2

## CITED REFERENCES

1 Westerman DA, Schwarer A, Grigg AP. (1998). Hydroxyurea-induced fever and hepatitis. Aust N Z J Med.

## ANNOTATED BIBLIOGRAPHY

References updated: 12 July 2021

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that hydroxyurea resembles urethane in structure and has been associated with hypersensitivity and hepatitis).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss hydroxyurea).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Hydroxyurea. Cytotoxic drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1195-6. (Textbook of pharmacology and therapeutics).
Moschella SL, Greenwald MA. (1973). Psoriasis with hydroxyurea. An 18-month study of 60 patients. Arch Dermatol. (Among 60 patients with severe psoriasis treated with hydroxyurea for up to 18 months, 63% had a beneficial response and side effects included marrow suppression, but none had AST elevations or hepatotoxicity; six patients developed fever and an influenza-like syndrome shortly after starting therapy and two redeveloped fever on rechallenge, but liver enzymes remained normal).
Heddle R, Calvert AF. (1980). Hydroxyurea induced hepatitis. Med J Aust. (64 year old male with psoriasis developed fatigue, nausea and fever, 18 days after starting hydroxyurea [bilirubin 1.6 mg/dL, AST 524 U/L, Alk P 128 U/L], resolving rapidly upon stopping and recurring with fever of 40 oC, drowsiness, delirium and mild elevations of serum enzymes within 5 hours, resolving within 2 days).
Bauman JL, Shulruff S, Hasegawa GR, Roden R, Hartsough N, Bauernfeind RA. (1981). Fever caused by hydroxyurea. Arch Intern Med. (56 year old woman with psoriasis developed spiking fevers without eosinophilia or rash after starting hydroxyurea, resolving rapidly on stopping and rapidly recurring on reexposure [liver enzymes were "mildly elevated", but bilirubin was normal]).
Sharon R, Tatarsky I, Ben-Arieh Y. (1986). Treatment of polycythemia vera with hydroxyurea. Cancer. (Among 36 patients with polycythemia vera treated with hydroxyurea for 1-5 years, 2 developed fever, 1 hyperbilirubinemia and 2 renal failure; ALT elevations and hepatotoxicity not mentioned).
Blonk MC, Ossenkoppele GJ. (1988). Hydroxyurea as a cause of drug fever in chronic myeloid leukaemia. Neth J Med. (63 year old man with CML developed fever 10 days after starting hydroxyurea, resolving rapidly on stopping and recurring rapidly with reexposure; no mention of liver test results).
Charache S, Terrin ML, Moore RD, Dover GJ, Barton FB, Eckert SV, McMahon RP, Bonds DR. (1995). Effect of hydroxyurea on the frequency of painful crises in sickle cell anemia. Investigators of the Multicenter Study of Hydroxyurea in Sickle Cell Anemia. N Engl J Med. (Among 299 patients with sickle cell disease treated with hydroxyurea or placebo for up to 2 years, pain crises were fewer in hydroxyurea treated subjects and hemoglobin levels were higher; serious adverse events included one patient with fulminant hepatitis in the hydroxyurea treated group, but no details provided).
Starmans-Kool MJ, Fickers MM, Pannebakker MA. (1995). An unwanted side effect of hydroxyurea in a patient with idiopathic myelofibrosis. Ann Hematol. (79 year old man with myelofibrosis developed fever and diarrhea 20 days after starting hydroxyurea [normal white counts, no mention of liver tests], which resolved within 24 hours of stopping).
Lossos IS, Matzner Y. (1995). Hydroxyurea-induced fever: case report and review of the literature. Ann Pharmacother. (63 year old man with essential thrombocytosis developed fever and flu-like symptoms within 24 hours of starting hydroxyurea [39 ^o^C] with normal white count and liver tests, resolving within 30 hours of stopping and recurring with reexposure 1 week and again 1 year later).
in 't Veld BA, Slappendel AM, Feenstra J, Veen C, van Aken J, Runhaar EA, Stricker BH. (1997). Fever attributed to the use of hydroxyurea. Neth J Med. (3 patients with essential thrombocythemia, 2 men and 1 woman, ages 67 to 70 years, developed fever [39-40 ^o^C] within 1-3 weeks of starting hydroxyurea accompanied by constitutional symptoms, resolving rapidly on stopping and recurring rapidly on restarting hydroxyurea; no mention of liver enzymes or jaundice).
van der Klooster JM, Sucec PM, Stiegelis WF, Hagenbeek A. (1997). Fever caused by hydroxyurea: a report of three cases and review of the literature. Neth J Med. (3 patients with myeloproliferative syndromes, 2 men and 1 woman, ages 54 to 80 years, developed fever [39-40 ^o^C] 2-4 weeks after starting hydroxyurea, resolving rapidly with stopping and recurring upon reexposure; two patients had mild liver enzyme abnormalities as well [bilirubin 1.1 mg/dL, ALT 108-124 U/L, Alk P 104-140 U/L]).
Westerman DA, Schwarer A, Grigg AP. (1998). Hydroxyurea-induced fever and hepatitis. Aust N Z J Med. (Four adult patients with myeloproliferative disorders [ages 45 to 68 years] developed fever [39-41 ^o^C] and hepatitis 3 weeks after starting hydroxyurea therapy [bilirubin 1.0, 1.5, 3.5 and 8.2 mg/dL, ALT 44, 208, 271, and 366 U/L, Alk P 530, 784, 909, and 1047 U/L], fever resolving within 24 hours of stopping and liver abnormalities within one month, with recurrence of fever within hours of reexposure).
Rutschmann OT, Opravil M, Iten A, Malinverni R, Vernazza PL, Bucher HC, Bernasconi E, et al. (1998). A placebo-controlled trial of didanosine plus stavudine, with and without hydroxyurea, for HIV infection. The Swiss HIV Cohort Study. AIDS. (Controlled trial of hydroxyurea vs placebo in 145 patients with HIV infection on didanosine and stavudine found no excess toxicity with addition of hydroxyurea, no mention of ALT elevations, hepatitis, liver failure or drug fever).
Gwilt PR, Tracewell WG. (1998). Pharmacokinetics and pharmacodynamics of hydroxyurea. Clin Pharmacokinet. (Hydroxyurea is hydroxylated analogue of urea and suppresses DNA replication by inhibition of ribonucleotide reductase, a necessary step in deoxyribonucleic acid synthesis; its hepatic metabolism is not well characterized, but is probably via the cytochrome P450 system; discussion of side effects mentions liver enzyme elevations).
Cheung AY, Browne B, Capen C. (1999). Hydroxyurea-induced fever in cervical carcinoma: case report and review of the literature. Cancer Invest. (52 year old woman with cervical cancer developed cyclic episodes of fever 4 weeks after starting hydroxyurea, stopping only with permanent discontinuation [eosinophils eventually rising to 14% with the third episode]).
Weissman SB, Sinclair GI, Green CL, Fissell WH. (1999). Hydroxyurea-induced hepatitis in human immunodeficiency virus-positive patients. Clin Infect Dis. (Two patients with HIV infection developed liver injury 2-3 months after adding hydroxyurea to an antiretroviral regimen of didanosine, stavudine and a protease inhibitor; a 45 year old woman developed acute liver failure [bilirubin 20 mg/dL, ALT 1245 U/L, Alk P 178 U/L] and died, and a 42 year old man developed mild jaundice [bilirubin 3.8 mg/dL, ALT 197 U/L, Alk P 166 U/L] and recovered slowly after stopping all drugs, and was later able to restart the antiretroviral regimen).
Shuster J. (2000). Hydroxyurea and hepatitis. Nursing. (Commentary on Weissman [1999] discusses the hepatotoxicity of the combination of hydroxyurea with antiretroviral agents).
Tsurumi H, Goto H, Hara T, Moriwaki H. (2000). Hydroxyurea-induced fever in a patient with chronic myelogenous leukemia. Int J Hematol. (57 year old man with CML developed fever and leg edema within a few months of starting hydroxyurea [albumin 2.1 g/dL], which persisted despite stopping interferon and resolved rapidly with stopping hydroxyurea, albumin levels slowly rising thereafter).
Rutschmann OT, Vernazza PL, Bucher HC, Opravil M, Ledergerber B, Telenti A, Malinverni R, et al. (2000). Long-term hydroxyurea in combination with didanosine and stavudine for the treatment of HIV-1 infection. Swiss HIV Cohort Study. AIDS. (Among 102 patients treated with hydroxyurea, didanosine and stavudine, only 24% remained on therapy long term, adverse events being common including fatigue, headache, neuropathy and thrombocytopenia; ALT or AST elevations occurred in 58% of patients receiving hydroxyurea vs 50% of those on didanosine and stavudine alone).
Braester A, Quitt M. (2000). Hydroxyurea as a cause of drug fever. Acta Haematol. (64 year old woman with essential thrombocytosis developed fever without liver test abnormalities 3 weeks after starting hydroxyurea, which resolved rapidly after stopping).
Pavic M, Sève P, Le Scanff J, Gomard E, Charhon A, Broussolle C. (2004). Rev Med Interne. (75 year old woman with polycythemia vera developed high fevers within 3 weeks of starting hydroxyurea, which resolved rapidly upon stopping and recurred within 12 hours of restarting; no mention of serum enzyme elevations).
Randi ML, Ruzzon E, Tezza F, Luzzatto G, Fabris F. (2005). Toxicity and side effects of hydroxyurea used for primary thrombocythemia. Platelets. (Among 152 patients with thrombocytosis treated with hydroxyurea [for a median of 8.3 years] at a single referral center, notable side effects included 5 patients with macrocytic anemia, 2 drug fever, 2 allergic reactions, 4 leg ulcers and 3 leukemia or myelodysplasia; no mention of ALT elevations or hepatotoxicity).
Hallam MJ, Kolesar JM. (2008). Hydroxyurea induced acute elevations in liver function tests. J Oncol Pharm Pract. (82 year old man with polycythemia vera developed nausea and fever 8 days after starting hydroxyurea, which resolved rapidly on stopping and recurred with liver test abnormalities on restarting [bilirubin 1.5 mg/dL, AST 50 U/L, Alk P 353 U/L], resolving within 7 days of stopping).
Lanzkron S, Strouse JJ, Wilson R, Beach MC, Haywood C, Park H, Witkop C, et al. (2008). Systematic review: Hydroxyurea for the treatment of adults with sickle cell disease. Ann Intern Med. (Systematic review of the efficacy and safety of hydroxyurea in the therapy of sickle cell disease discusses embryotoxicity, myelosuppression and potential carcinogenesis of hydroxyurea, but does not mention ALT elevations or hepatotoxicity).
Brawley OW, Cornelius LJ, Edwards LR, Gamble VN, Green BL, Inturrisi C, James AH, et al. (2008). National Institutes of Health Consensus Development Conference statement: hydroxyurea treatment for sickle cell disease. Ann Intern Med. (Consensus statement on use of hydroxyurea in patients with sickle cell disease).
Platt OS. (2008). Hydroxyurea for the treatment of sickle cell anemia. N Engl J Med. (Review of the mechanism of action, efficacy and safety of hydroxyurea therapy of sickle cell disease mentions potential of embryotoxicity, myelotoxicity and cancer, but does not discuss ALT elevations or hepatotoxicity).
Rees DC, Williams TN, Gladwin MT. (2010). Sickle-cell disease. Lancet. (Review of the pathogenesis, clinical features, natural history, complications, management and therapy of sickle cell disease).
Italia KY, Jijina FF, Jain D, Merchant R, Nadkarni AH, Mukherjee M, Ghosh K, et al. (2010). The effect of UGT1A1 promoter polymorphism on bilirubin response to hydroxyurea therapy in hemoglobinopathies. Clin Biochem. (Genetic analyses of 112 patients with hemoglobinopathies receiving hydroxyurea found higher total bilirubin levels in patients with [TA]7/[TA]7 repeats, typical of Gilbert syndrome).
Steinberg MH, McCarthy WF, Castro O, Ballas SK, Armstrong FD, Smith W, Ataga K, et al., Investigators of the Multicenter Study of Hydroxyurea in Sickle Cell Anemia and MSH Patients' Follow-Up. (2010). The risks and benefits of long-term use of hydroxyurea in sickle cell anemia: A 17.5 year follow-up. Am J Hematol. (Long term follow up of patients with sickle cell disease in a clinical trial of hydroxyurea found evidence of improved survival without apparent severe adverse events; liver disease occurred in 6% of patients and was less in hydroxyurea treated subjects and person who survived more than 10 years).
Ebert EC, Nagar M, Hagspiel KD. (2010). Gastrointestinal and hepatic complications of sickle cell disease. Clin Gastroenterol Hepatol. (Review of the liver complications of sickle cell disease mentions hepatic crises, infarction, viral hepatitis, iron overload, and nodular regenerative hyperplasia, but not drug induced liver injury).
Miller ST, Rey K, He J, Flanagan J, Fish BJ, Rogers ZR, Wang WC, Ware RE, BABY HUG Investigators. (2012). Massive accidental overdose of hydroxyurea in a young child with sickle cell anemia. Pediatr Blood Cancer. (A 2 year old child with sickle cell disease on long term hydroxyurea ingested an entire bottle of drug [~612 mg/kg], but remained well and asymptomatic during follow up with no change in serum ALT and only mild decrease in white blood cell counts, later restarting hydroxyurea).
Antonioli E, Guglielmelli P, Pieri L, Finazzi M, Rumi E, Martinelli V, Vianelli N, et al. (2012). AGIMM Investigators. Hydroxyurea-related toxicity in 3,411 patients with Ph'-negative MPN. Am J Hematol. (Retrospective analysis of side effects of hydroxyurea therapy in 3411 patients treated in multiple Italian centers between 1980 and 2000, found notable side effects in 184 [5%], including 16 with fever, 167 with skin ulcers and one with pneumonitis; no mention of ALT elevations or hepatotoxicity).
Hua J, Iwaki Y, Inoue M, Hagihara M. (2013). Tumor lysis syndrome soon after treatment with hydroxyurea followed by nilotinib in two patients with chronic-phase chronic myelogenous leukemia. Int J Hematol. (Two patients with CML developed tumor lysis syndrome 1 and 4 days after starting nilotinib, both having been pretreated with hydroxyurea to decrease the white count; the first patient recovering and subsequently tolerating hydroxyurea and nilotinib treatment without recurrence; the second patient developing renal insufficiency followed by acute hepatic necrosis [bilirubin 4.4 mg/dL, ALT 1031 U/L], disseminated intravascular coagulation and multiorgan failure and death).
Doutrelon C, Lazaro E, Ribeiro E, Greib C, Pellegrin JL, Viallard JF. (2015). Rev Med Interne. (Description of 4 new cases of hydroxyurea induced fever and review of the literature identified 42 cases, mean age 65 years, median onset at 21 days, one third with accompanying hepatitis or pulmonary complications).
Shimizu T, Mori T, Karigane D, Kikuchi T, Koda Y, Toyama T, Nakajima H, et al. (2014). Rinsho Ketsueki. (Abstract only: 62 year old man with myelodysplastic syndrome developed fever and nausea 8 days after starting hydroxyurea [bilirubin not given, ALT 5098 U/L], with resolution within 2 weeks of stopping).
Malik A, Merchant C, Rao M, Fiore RP. (2015). Rare but lethal hepatopathy-sickle cell intrahepatic cholestasis and management strategies. Am J Case Rep. (31 year old man with sickle cell disaese developed a vaso-occlusive crises with abdominal pain and jaundiced [bilirubin 4.0 rising to 50 mg/dL, ALT 78 U/L, Alk P 274 U/L]).
Barrier A, Willy S, Slone JS. (2015). Extramedullary hematopoiesis of the liver in a child with sickle cell disease: a rare complication. Pediatr Int. (7 year old girl with sickle cell disease with large hepatic mass was found to be due to severe extramedullary hematopoiesis, dying of respiratory failure despite treatment with hydroxyurea and blood transfusions).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to hydroxyurea).
Koh C, Turner T, Zhao X, Minniti CP, Feld JJ, Simpson J, Demino M, et al. (2013). Liver stiffness increases acutely during sickle cell vaso-occlusive crisis. Am J Hematol. (Among 23 patients with sickle cell disease evaluated before and during an acute vaso-occlusive crisis, serum liver enzyme elevations did not change appreciably but hepatic stiffness increased [measured by ultrasound transient elastography] as did serum total and indirect bilirubin and reticulocyte counts, while serum albumin and hemoglobin decreased).
Feld JJ, Kato GJ, Koh C, Shields T, Hildesheim M, Kleiner DE, Taylor JG, et al. (2015). Liver injury is associated with mortality in sickle cell disease. Aliment Pharmacol Ther. (Among 247 patients with sickle cell disease, liver disease was common, elevations in ALT were present in 16% and alkaline phosphatase in 33%; factors associated with mortality during follow up were iron indices [serum ferritin, transferrin, and iron] and liver abnormalities [direct bilirubin, albumin and alkaline phosphatase levels]; liver biopsy done in 40 patients revealed nodular regenerative hyperplasia in 36% and portal venopathy in 23%).
Fitzhugh CD, Hsieh MM, Allen D, Coles WA, Seamon C, Ring M, Zhao X, et al. (2015). Hydroxyurea-increased fetal hemoglobin is associated with less organ damage and longer survival in adults with sickle cell anemia. PLoS One. (Among 383 adults with sickle cell disease followed for up to 19 years [median=2.6 years], 59 [15%] died largely from pulmonary or cardiac disease, sickle crises or infections, and use of higher doses of hydroxyurea were associated with higher HbF levels, lower ALT values and better survival).
Malik A, Merchant C, Rao M, Fiore RP. (2015). Rare but lethal hepatopathy-sickle cell intrahepatic cholestasis and management strategies. Am J Case Rep. (31 year old man with sickle cell disease presented with a severe vaso-occlusive crisis, right upper quadrant pain and marked jaundice [total bilirubin 50 mg/dL, direct 38 mg/dL, ALT 40 U/L, AST 155 U/L, Alk P 320 U/L], eventually recovering with blood transfusions and supportive care).
Tisdale JF, Thein SL, Eaton WA. (2020). Treating sickle cell anemia. Science. (Review of mechanism of action and efficacy of current [hydroxyurea and voxelotor] and the promise of future therapies of sickle cell anemia [including bone marrow transplantation and gene therapy], mentions that the increase in HbF induced by hydroxyurea dilutes HbS concentrations making sickling less likely to occur in the time of transit of red cells through the microvasculature).
Osunkwo I, Manwani D, Kanter J. (2020). Current and novel therapies for the prevention of vaso-occlusive crisis in sickle cell disease. Ther Adv Hematol. (Review of the pathogenesis of vaso-occlusive crises in sickle cell disease and drugs that target different components of the multifactorial process including increasing fetal hemoglobin [hydroxyurea], decreasing oxidative stress [L-glutamine], increasing oxygen affinity of hemoglobin [voxelotor], and decreasing adhesion of sickled cells to platelets, neutrophils and endothelium [crizanlizumab]; no mention of ALT elevations with therapy or hepatotoxicity).
Darbari DS, Sheehan VA, Ballas SK. (2020). The vaso-occlusive pain crisis in sickle cell disease: definition, pathophysiology, and management. Eur J Haematol. (Extensive review of the pathogenesis of vaso-occlusive crisis in patients with sickle cell disease and therapies that target different steps in the process including inflammation, adhesion, oxidative stress and oxygen affinity and stability of hemoglobin; discusses efficacy of L-glutamine, voxelotor and crizanlizumab, mentioning that all three are well tolerated; no mention or discussion of hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Hydroxyurea: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Hydroxyurea+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Hydroxyurea: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hydroxyurea)